# Fluvastatin

## OVERVIEW

### Introduction

Fluvastatin is a commonly used cholesterol lowering agent (statin) that is associated with mild, asymptomatic and self-limited serum aminotransferase elevations during therapy and rarely with clinically apparent acute liver injury.

### Background

Fluvastatin (floo" va stat' in) is an orally available inhibitor of hepatic 3-hydroxy-3-methylglutaryl-coenzyme A (HMG-CoA) reductase, the major rate-limiting enzyme in cholesterol synthesis. Like other members of its class (the “statins”), fluvastatin lowers total serum cholesterol and low density lipoprotein (LDL) concentrations, thereby reducing the risk of atherosclerosis and its complications – myocardial infarction and stroke. Fluvastatin is indicated for treatment of hypercholesterolemia in persons at high risk for coronary, cerebrovascular and peripheral artery disease and to decrease the risk of mortality from cardiovascular disease. Fluvastatin is available in capsules of 20 and 40 mg and as extended release tablets of 40 and 80 mg generically and under the brand names Lescol and Lescol XL. The recommended daily dose is 20 to 80 mg in one or two divided doses based upon tolerability and lipid levels. Fluvastatin was approved for use in the United States in 1993 and remains a commonly prescribed drug with more than one million prescriptions filled yearly. Common side effects include muscle cramps, joint aches, abdominal pain, nausea, headache and weakness, symptoms that occur with all of the currently available statins. Rare but potentially severe adverse events include liver injury, myopathy, rhabdomyolysis, and immune-mediated necrotizing myopathy.

### Hepatotoxicity

Fluvastatin therapy is associated with mild, asymptomatic and usually transient serum aminotransferase elevations in 1% to 5% of patients but in levels above 3 times ULN is approximately 1%. In summary analyses of large scale studies with prospective monitoring, ALT elevations above normal occurred in up to 5% of patients; ALT levels of above 3 times the upper limit of normal (ULN) occurred in 1.1% of fluvastatin treated versus 0.3% of placebo recipients. These elevations were more common with higher doses of fluvastatin. Most of these elevations were self-limited and did not require dose modification. Fluvastatin is the statin most commonly associated with serum aminotransferase elevations and the highest rates of symptomatic liver injury, yet frank, clinically apparent hepatic injury from fluvastatin is still quite rare estimated to occur in 1.7 per 10,000 person years of use. In the few cases that have been reported, the onset of clinical injury has been within 1 to 4 months, the pattern of injury is typically cholestatic or mixed. Rash, fever and eosinophilia are uncommon. At least one case with features of autoimmunity has been described. Most cases resolve within a few months of onset. Rare cases of acute liver failure and death have been attributed to fluvastatin.

Likelihood score: B (likely rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of hepatic injury from fluvastatin is unknown. Fluvastatin is largely metabolized in the liver (via several P450 enzymes, largely CYP 2C9) and excreted in bile. The mild, self-limited ALT elevations are likely due to direct hepatotoxicity from an intermediate of drug metabolism and the reversal of these elevations due to adaptation. The idiosyncratic, clinically apparent liver injury associated with fluvastatin may be due to hypersensitivity or to a failure of adaptation.

### Outcome and Management

The product label for fluvastatin recommends screening for liver test abnormalities before starting therapy and repeating tests as clinically indicated. In most instances, the minor elevations in serum ALT levels that occur during fluvastatin therapy are self-limited and resolve even with continuation of the drug. Discontinuation is recommended for any elevation above 10 times and for persistent elevations above 5 times the ULN. Cases of clinically apparent hepatic injury from fluvastatin are also usually self-limited and resolve within 1 to 2 months. Cases of chronic hepatitis and vanishing bile duct syndrome have not been reported. In view of the wide scale use of fluvastatin, clinically apparent and severe liver injury is extraordinarily rare. Recurrence of injury with rechallenge has been reported and should be avoided. Switching therapy to another statin after fluvastatin induced injury is apparently safe, but few instances have been reported, and it should be done with careful monitoring for recurrence.

Drug Class: Antilipemic Agents

Other Drugs in the Subclass, Statins: Atorvastatin, Ezetimibe [used in combination], Lovastatin, Pitavastatin, Pravastatin, Rosuvastatin, Simvastatin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fluvastatin – Generic, Lescol®

DRUG CLASS

Antilipemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=fluvastatin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Fluvastatin | 93957-55-2 | C24-H26-F-N-O4.Na

## ANNOTATED BIBLIOGRAPHY

References updated: 01 December 2021

Abbreviations used: ANA, antinuclear antibody; HDL, high density lipoprotein; LDL, low density lipoprotein; OD, odds ratio.

Zimmerman HJ. Drugs used in the treatment of hypercholesterolemia and hyperlipidemia. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 660-2. (Expert review of hepatotoxicity published in 1999, mentions that the statins have dose related hepatic effects in guinea pigs and rabbits and transient elevations in aminotransferases occur in 1-5% of humans treated; several cases of clinically apparent liver injury from lovastatin and simvastatin have been published).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs. Lipid regulating agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 526-7. (Review of hepatotoxicity of lipid lowering agents; elevations in serum enzymes occur in up to 3% of patients, usually within first 3 months of therapy, apparently a class effect).
Gurgle H, Blumenthal DK. Drug therapy for dyslipidemias. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 605-618. (Textbook of pharmacology and therapeutics; “Serious hepatotoxicity is rare and unpredictable, with a rate of about 1 case per million person-years of use.” Multiple academic societies and the FDA recommend testing all patients for routine liver tests before starting statins but monitoring or retesting only if symptoms arise).
Jokubaitis LA. (1994). Updated clinical safety experience with fluvastatin. Am J Cardiol. (Review of safety of fluvastatin from studies of 1881 patients and 747 controls treated for an average of 61 weeks; rates of ALT elevations greater than 3 times ULN were 1.3% with fluvastatin vs 0.5% with placebo).
Jacobson TA, Amorosa LF. (1994). Combination therapy with fluvastatin and niacin in hypercholesterolemia: a preliminary report on safety. Am J Cardiol. (Controlled trial of fluvastatin vs placebo followed by addition of niacin in 74 patients; ALT elevations occurred in 5.3% on fluvastatin and niacin compared to 6.5% of niacin alone; no case of clinically apparent liver injury).
Gascon A, Zabala S, Iglesuas E. (1999). Acute cholestasis during long-term treatment with fluvastatin in a nephrotic patient. Nephrol Dial Transplant. (71 year old man developed elevations in ALT [210 U/L], GGT [1818 U/L] and Alk P [472 U/L], without symptoms or jaundice 7 months after starting fluvastatin and 2 months after increasing the dose; serum enzymes returned to normal 2 weeks after stopping and recurred upon restarting [GGT 532 U/L] fluvastatin, but remaining normal after switching to simvastatin).
Lawrence JM, Reckless JP. (2002). Fluvastatin. Expert Opin Pharmacother. (Review of chemistry, pharmacology, metabolism, clinical efficacy and safety of fluvastatin; “All statins may cause elevations in liver function tests, which are usually dose-dependent, and fluvastatin is no exception.” Confirmed ALT elevations >3 times ULN occur in 0.2% of patients on 20 mg, 1.5% on 40 mg, and 2.7% on 80 mg of fluvastatin daily).
Hartleb M, Biernat L, Kochel A. (2002). Drug-induced liver damage – a three-year study of patients from one gastroenterological department. Med Sci Monit. (14 patients with drug induced liver injury seen in one hospital [Silesian Medical University] over 3 year period; amoxicillin/clavulanate in 3, antituberculosis agents in 2, pravastatin in 2, fluvastatin in 1 and 6 other agents in 1 each; fluvastatin case was a 49 year old with onset after 3 weeks of therapy [bilirubin 1.4 mg/dL, ALT 10.5 times and Alk P 5.0 times ULN], ultimately resolving).
Parra JL, Reddy KR. (2003). Hepatotoxicity of hypolipidemic drugs. Clin Liver Dis. (Review and discussion of individual lipid lowering agents; little information on fluvastatin).
Kiortsis DN, Nikas S, Hatzidimou K, Tsianos E, Elisaf MS. (2003). Lipid-lowering drugs and serum liver enzymes: the effects of body weight and baseline enzyme levels. Fundam Clin Pharmacol. (Among 163 patients treated with various lipid lowering drugs, the proportion with elevated ALT levels was 9.1% before treatment, 9.5% at 8 weeks and 9.1% at 24 weeks; similar at all body weights, but ALT elevations more frequent in obese and overweight subjects).
de Denus S, Spinler SA, Miller K, Peterson AM. (2004). Statins and liver toxicity: a meta-analysis. Pharmacotherapy. (Systematic review of 13 large controlled trials of statins with at least 48 weeks of therapy in 43,390 patients; overall odds ratio for liver test abnormalities with statins versus placebo was 1.26; lovastatin 1.78; simvastatin 1.06; pravastatin 1.00, and fluvastatin, 3.54).
Chalasani N, Aljadhey H, Kesterson J, Murray MD, Hall SD. (2004). Patients with elevated liver enzymes are not at higher risk for statin hepatotoxicity. Gastroenterology. (Retrospective analysis of electronic records found similar rates of severe ALT or AST elevations with or without statin [atorvastatin, simvastatin or fluvastatin] therapy [0.6% vs 0.4%] in patients with elevations at baseline).
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al., Spanish Group for the Study of Drug-Induced Liver Disease. (2005). Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology. (Analysis of 461 cases of drug induced liver disease reported between 1984 to 2004 in a Spanish Registry; 11 cases were attributed to “statins”, but no specific agent mentioned and none caused more than 4 cases).
Khorashadi S, Hasson NK, Cheung RC. (2006). Incidence of statin hepatotoxicity in patients with hepatitis C. Clin Gastroenterol Hepatol. (Electronic record review of rate of ALT elevations in patients with hepatitis C with or without statin therapy and controls on statin therapy found no differences between the three groups [20%, 24% and 17%]; severe abnormalities most frequent in patients with chronic hepatitis C, not on statin [6.6% vs 1.2%]).
Silva MA, Swanson AC, Gandhi PJ, Tataronis GR. (2006). Statin-related adverse events: a meta-analysis. Clin Ther. (Metaanalysis of adverse event rates in 18 placebo controlled trials of six statins in 71,108 patients; ALT elevations greater than 3 times ULN in 1.7% of statin vs 1.4% placebo recipients; event rates highest with atorvastatin, lowest with fluvastatin).
Conforti A, Magro L, Moretti U, Scotto S, Motola D, Salvo F, Ros B, et al. (2006). Fluvastatin and hepatic reactions: a signal from spontaneous reporting in Italy. Drug Safety. (Italian Pharmacovigilance Group review of 35,757 adverse reaction reports, 1260 due to statins of which 178 were hepatic: 69 [36%] fluvastatin, 37 [21%] atorvastatin, 50 [28%] simvastatin, 16 [9%] pravastatin, 6 [3%] rosuvastatin; proportion reporting rate based on number of prescriptions was highest for fluvastatin [~9] compared to other agents [~2-3]; 26 fluvastatin cases described as “hepatitis”, but no details given except that most cases occurred within 90 days of starting).
Law M, Rudnicka AR. (2006). Statin safety: a systematic review. Am J Cardiol. (Review of safety of statins; 38 cases of acute liver failure attributed to statins were submitted to MedWatch by end of 1999, which gave an estimated rate of 1 per million person years of use; rate of confirmed ALT elevations above 3 times ULN was 0.1% with statins and 0.04% with placebo).
Chen YW, Lai HW, Wang TD. (2007). Marked elevation of liver transaminases after high-dose fluvastatin unmasks chronic hepatitis C: safety and rechallenge. Acta Neurol Taiwan. (85 year old woman developed elevations in ALT [409 U/L] 6 weeks after starting fluvastatin [80 mg daily] and was found to have hepatitis C, but restarting fluvastatin and switching to simvastatin also led to ALT elevations; eventually, long term fluvastatin was tolerated and ALT levels returned to normal).
Castiella A, Fernanzez J, Zapata E. (2007). Autoimmune hepatitis after treatment with fluvastatin. Liver Int. (67 year old man developed anicteric hepatitis [ALT 791 U/L, Alk P 1661 U/L, ANA 1:160, HLA-DR3], ultimately requiring prednisone and azathioprine).
Akoglu H, Yilmaz K, Kirkpantur A, Arici M, Altun B, Turgan C. (2007). Combined organ failure with combination antihyperlipidemic treatment: a case of hepatic injury and acute renal failure. Ann Pharmacother. (56 year old developed rhabdomyolysis 1 month after starting fluvastatin [bilirubin and Alk P normal, ALT 2100 U/L, LDH 45,758], resolving within 15 days).
Bhardwah SS, Chalasani N. (2007). Lipid-lowering agents that cause drug-induced hepatotoxicity. Clin Liver Dis. (Review of hepatotoxicity of statins; reported rates of ALT or AST elevations above 3 times ULN are atorvastatin 0.7%, fluvastatin 1.2%, lovastatin 0.6%, pravastatin 1.4%, rosuvastatin 0% and simvastatin 1.8%; elevations were usually asymptomatic, individual case reports of autoimmune hepatitis).
Alsheikh-Ali AA, Maddukuri PV, Han H, Karas RH. (2007). Effect of the magnitude of lipid lowering on risk of elevated liver enzymes, rhabdomyolysis, and cancer: insights from large randomized statin trials. J Am Coll Cardiol. (Systematic review of relationship between LDL cholesterol lowering effects and adverse events in 23 statin treatment arms representing 309,506 person years of therapy; positive and graded relationship between statin dose [simvastatin, lovastatin and atorvastatin] and rates of ALT elevations, but no independent relationship to degree of LDL cholesterol decrease).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 3 cases were attributed to atorvastatin, 3 to simvastatin/ezetimibe, and one each to pravastatin, fluvastatin, and simvastatin, but most cases were mild or not always clearly attributable to the statin therapy).
Martin JE, Cavanaugh TM, Trumbull L, Bass M, Weber F, Aranda-Michel J, Hanaway M, et al. (2008). Incidence of adverse events with HMG-CoA reductase inhibitors in liver transplant patients. Clin Transplant. (Retrospective review of adverse events associated with statin and fibrate use in 69 patients with liver transplants; myalgias problematic in 5, myopathy in 1, but none had significant ALT elevations or hepatitis related to medication).
Neuvonen PJ, Backman JT, Niemi M. (2008). Pharmacokinetic comparison of the potential over-the-counter statins simvastatin, lovastatin, fluvastatin and pravastatin. Clin Pharmacokinet. (Review of literature on pharmacokinetics of statins; simvastatin and lovastatin are metabolized extensively by the P450 system and levels are affected by inhibitors or inducers of CYP 3A4 [itraconazole, erythromycin, verapamil, diltiazem, cyclosporine], whereas fluvastatin and pravastatin are minimally, if at all, affected).
Bader T, Fazili J, Madhoun M, Aston C, Hughes D, Rizvi S, Seres K, et al. (2008). Fluvastatin inhibits hepatitis C replication in humans. Am J Gastroenterol. (Open labeled study in 31 men with chronic hepatitis C given fluvastatin at doses of 80 to 320 mg daily for 2-12 weeks; no worsening of serum ALT levels and slight decrease in HCV RNA levels during therapy).
Russo MW, Scobey M, Bonkovsky HL. (2009). Drug-induced liver injury associated with statins. Semin Liver Dis. (Case reports and review of literature; 52 year old woman who developed fatigue 12 weeks after starting fluvastatin [bilirubin 1.2 mg/dL, ALT 850 U/L, Alk P 215 U/L, ANA negative], resolving on stopping fluvastatin but recurring within 11 weeks of starting atorvastatin [bilirubin 1.0 rising to 12.5 mg/dL, ALT 1750 U/L, Alk P 285 U/L, ANA 1:160], responding to prednisone and azathioprine therapy).
Hippisley-Cox J, Coupland C. (2010). Unintended effects of statins in men and women in England and Wales: population based cohort study using the QResearch database. BMJ. (Among 225,922 new users of statins in a UK health care database, there was an increased risk of moderate or severe liver dysfunction [ALT above 3 times ULN], usually within first 6 months and associated with higher doses of statins; relative risks were highest with fluvastatin [2.53 in women, 1.97 in men] and lowest with pravastatin [0.93 to 1.58]).
Nakayama S, Murashima N. (2011). Overlap syndrome of autoimmune hepatitis and primary biliary cirrhosis triggered by fluvastatin. Indian J Gastroenterol. (59 year old man developed serum enzyme elevations 1 month after starting fluvastatin [bilirubin 1.1 rising to 3.1 mg/dL, ALT 1010 U/L, Alk P 303 U/L, ANA 1:1280, AMA positive, IgG 2031 mg/dL], liver biopsy showing changes of autoimmune hepatitis and bile duct loss, subsequently liver tests fell to normal on prednisone).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 2 due to atorvastatin, 2 simvastatin and 2 cerivastatin, but none to fluvastatin).
Björnsson E, Jacobsen EI, Kalaitzakis E. (2012). Hepatotoxicity associated with statins: reports of idiosyncratic liver injury post-marketing. J Hepatol. (Between 1988 and 2010, the Swedish registry received 217 adverse event reports possibly related to statins, 124 [57%] being liver related, 73 of which could be evaluated: 2 were fatal and one led to liver transplant; 3 had positive rechallenge; 43 [59%] were hepatocellular, 22 [30%] cholestatic and 8 [11%] mixed; 30 were due to atorvastatin, 28 simvastatin, 11 fluvastatin, 2 pravastatin and 2 rosuvastatin, arising after 30 to 248 days; fluvastatin had the highest estimated rate per daily dose of 17/10,000 person years compared to 1.6 overall).
Sirtori CR, Mombelli G, Triolo M, Laaksonen R. (2012). Clinical response to statins: mechanism(s) of variable activity and adverse effects. Ann Med. (Review of the possible mechanisms for the beneficial and adverse effects of statins including genetic variations in CYP enzymes, ABC transporters and HLA genes in causing adverse events, focused mostly upon myopathy and myalgias).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 2 cases attributed to atorvastatin and 1 to simvastatin, but none to fluvastatin).
(2014). Drugs for lipids. Treat Guidel Med Lett. (Concise recommendations on management of hyperlipidemia mentions that 1-2% of patients on high doses of statins develop ALT elevations [above 3 times ULN], but that there is not always cross sensitivity to this side effect and that patients with mild-to-moderate ALT elevations can tolerate statins; no discussion of clinically apparent liver injury).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to statins or lipid lowering agents).
Russo MW, Hoofnagle JH, Gu J, Fontana RJ, Barnhart H, Kleiner DE, Chalasani N, et al. (2014). Spectrum of statin hepatotoxicity: Experience of the drug-induced liver injury network. Hepatology. (Among 1,188 cases of drug induced liver disease collected in the US between 2004 to 2012, 22 [2%] were attributed to statins, including atorvastatin [8], simvastatin [5], rosuvastatin [4], fluvastatin [2], pravastatin [2] and lovastatin [1]; median age was 60 years and 68% were women; 9 cases were cholestatic and 12 hepatocellular [6 with autoimmune features]; the latency ranged widely, from 1 month to 10 years; only one case due to atorvastatin was fatal [a man with preexisting cirrhosis presenting with acute-on-chronic liver failure]).
Bays H, Cohen DE, Chalasani N, Harrison SA. (2014). An assessment by the Statin Liver Safety Task Force: 2014 update. J Clin Lipidol. (Review of the safety of statins including their use in patients with liver disease recommending that liver tests be obtained before therapy, but that routine monitoring is not necessary and that statins can be safety used in patients with nonalcoholic liver disease, and are probably safe in other forms of chronic liver disease and after liver transplantation).
Ooba N, Sato T, Wakana A, Orii T, Kitamura M, Kokan A, Kurata H, et al. (2014). A prospective stratified case-cohort study on statins and multiple adverse events in Japan. PLoS One. (Among 6877 patients started on statins between 2008 and 2010, 139 developed an increase in ALT or AST deemed likely due to the drug with no significant differences among those treated with pra-, ator-, flu-, pita- or rosu-vastatin).
Macedo AF, Taylor FC, Casas JP, Adler A, Prieto-Merino D, Ebrahim S. (2014). Unintended effects of statins from observational studies in the general population: systematic review and meta-analysis. BMC Med. (Systematic review of 90 studies of 48 different "unintended effects" of statins with evidence of an increased risk of myopathy [Odds Ratio: OR=2.6] and raised liver enzymes [OR=1.5]).
Perdices EV, Medina-Cáliz I, Hernando S, Ortega A, Martín-Ocaña F, Navarro JM, Peláez G, et al. (2014). Hepatotoxicity associated with statin use: analysis of the cases included in the Spanish Hepatotoxicity Registry. Rev Esp Enferm Dig. (Among 858 cases of drug induced liver injury enrolled in a Spanish Registry between 1994 and 2012, 47 [5.5%] were attributed to statins [16 atorvastatin, 13 simvastatin, 12 fluvastatin, 4 lovastatin and 2 pravastatin], usually with a hepatocellular pattern of injury, 8.5% with autoimmune features, chronic injury in 19%, and no liver related deaths).
Li L, Ma Y, Geng XB, Song YX, Tan Z, Shang XM, Zhao GY, et al. (2016). Drug-induced acute liver injury within 12 hours after fluvastatin therapy. Am J Ther. (52 year old Chinese man on rosuvastatin started fluvastatin [80 mg/day] and developed fever, nausea and weakness after the first dose [bilirubin 3.2 mg/dL, ALT 421 U/L, Alk P 115 U/L], with return of tests to normal within 1 week, only to have a recurrence of the same symptoms, blood test abnormalities, and outcome on rechallenge with a single 80 mg dose one year later).
Chen GL, Hsiao FY, Dong YH, Shen LJ, Wu FL. (2014). Statins and the risk of liver injury: a population-based case-control study. Pharmacoepidemiol Drug Saf. (Among 2165 Taiwanese patients hospitalized for liver injury between 2002 and 2009, use of statins was not more frequent than among 16,600 hospitalized controls, except for use of high doses of rosuvastatin [adjusted odds ratio of 2.29]).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 31 cases [3.4%] were attributed to statins, including 8 to atorvastatin, 8 simvastatin, 7 rosuvastatin, 4 pravastatin, 2 fluvastatin and 2 lovastatin).
Chang CH, Chang YC, Lee YC, Liu YC, Chuang LM, Lin JW. (2015). Severe hepatic injury associated with different statins in patients with chronic liver disease: a nationwide population-based cohort study. J Gastroenterol Hepatol. (Among 37,929 Taiwanese persons with chronic liver disease started on statin therapy for hyperlipidemia between 2005 and 2009, there were 912 incident cases of hospitalization for liver injury, rates being similar for the 6 different statins used [1.94-2.95 per 100,000 person-days], but higher in those on high doses of atorvastatin [40 or 80 mg daily]).
Kim HS, Lee SH, Kim H, Lee SH, Cho JH, Lee H, Yim HW, et al. (2016). Statin-related aminotransferase elevation according to baseline aminotransferases level in real practice in Korea. J Clin Pharm Ther. (Among 21,233 Korean patients starting statin therapy between 2009 and 2013, abnormal ALT or AST values above 3 times ULN were more frequent among those with mild baseline elevations).
Wang LY, Huang YS, Perng CL, Huang B, Lin HC. (2016). Statin-induced liver injury in an area endemic for hepatitis B virus infection: risk factors and outcome analysis. Br J Clin Pharmacol. (Analysis of the Taipei Veterans Hospital database from 2008 to 2012 identified 108 patients with statin-associated liver injury [including 28 rosu-, 20 flu-, 17 sim-, 11 pra-, 8 lo-, and 8 pita-vastatin] most of which 75 [69%] were mild and only one fatal [80 year old on rosu-], and there were no differences in disease features or peak enzyme or bilirubin levels between HBsAg positive vs negative subjects [n=16 vs 92]).
Björnsson ES. (2017). Hepatotoxicity of statins and other lipid-lowering agents. Liver Int. (Review of the hepatotoxicity of statins mentions that 28 cases of fluvastatin associated liver injury have been published including examples of positive rechallenge and autoimmune phenotype, but no case has been fatal and chronicity is rare).
Giugliano RP, Wiviott SD, Blazing MA, De Ferrari GM, Park JG, Murphy SA, White JA, et al. (2017). Long-term safety and efficacy of achieving very low levels of low-density lipoprotein cholesterol: a prespecified analysis of the IMPROVE-IT Trial. JAMA Cardiol. (Among 15,281 patients recovering from an acute cardiac syndrome treated with simvastatin [40 mg daily] with or without ezetimibe for up to 6 years, 6.4% achieved very low LDL-cholesterol levels [<30 mg/dL] and subsequently had low rates of cardiovascular events but also no increase in rates of adverse events from statins such including ALT elevations above 3 times ULN [2.2% vs 1.8-2.1%]).
Liang X, He Q, Zhao Q. (2018). Effect of stains on LDL reduction and liver safety: a systematic review and meta-analysis. Biomed Res Int. (In a systematic review of 16 controlled trials of statins in 74,078 patients, rates of liver test abnormalities were higher with statin therapy [odds ratio, OR=1.18] but this was significant only for fluvastatin [OR=3.5] and with higher doses [40-80 mg daily] [OD=3.6] and was not significant for statins used at low or moderate doses).
Yebyo HG, Aschmann HE, Kaufmann M, Puhan MA. (2019). Comparative effectiveness and safety of statins as a class and of specific statins for primary prevention of cardiovascular disease: A systematic review, meta-analysis, and network meta-analysis of randomized trials with 94,283 participants. Am Heart J. (Metaanalyses of 40 trials of statins that enrolled 94,283 patients followed for a median of 1 year for efficacy and safety reported that statins as a class increased the risk of hepatic dysfunction by 6% with fluvastatin having the highest relative risk).
(2019). Lipid-lowering drugs. Med Lett Drugs Ther. (Concise review of the mechanism of action, relative efficacy, safety and costs of lipid lowering drugs including statins, ezetimibe, PCSK9 inhibitors, bile acid sequestrants, fibric acid derivatives niacin and fish oil, mentions that statin therapy is associated with ALT elevations above 3 times ULN in 1-3% of patients but “whether statins actually cause liver damage is unclear”).
Hung TH, Tsai CC, Lee HF. (2019). Statin use in cirrhotic patients with infectious diseases: A population-based study. PLoS One. (Analysis of the Taiwan National Health Insurance Database identified 816 patients with cirrhosis receiving statins [including fluvastatin] who were hospitalized for bacterial infections and similar number of cirrhotic controls not on statins, found a lower 30-day mortality with statins: 5.3% vs 9.8%).
Simon TG. (2020). When less is more: dosing simvastatin in decompensated cirrhosis. Lancet Gastroenterol Hepatol. (Editorial in response to Pose et al [2020] discusses the possible beneficial effects of statins in patients with cirrhosis and the issue of increased rate of muscle toxicity with 40 vs to 20 mg daily).
Hopewell JC, Offer A, Haynes R, Bowman L, Li J, Chen F, Bulbulia R, et al. (2020). Independent risk factors for simvastatin-related myopathy and relevance to different types of muscle symptom. Eur Heart J. (In a combined analysis of 3 large clinical trials in patients with cardiovascular disease treated with simvastatin for a mean of 3.4 years, 171 of 58,390 participants [0.1%] developed myopathy [muscle pain and CK levels above 10 times ULN], and risk was higher with higher doses, in Asian subjects, women, and persons with higher BMI and multiple comorbidities as well as with SLCO1B1 genotype).
Balasubramanian R, Maideen NMP. (2021). HMG-CoA reductase inhibitors (statins) and their drug interactions involving CYP enzymes, P-glycoprotein and OATP transporters-an overview. Curr Drug Metab. (Systematic review of literature on drug-drug interactions with statins and their clinical significance mentions that toxicity can be enhanced by inhibitors of CYP3A4 [ator-, sim- and lo-vastatin] as well as by inhibitors of P glycoprotein and OATP1B1 [most statins including rosuvastatin] with specific recommendations for the most common inhibitors).
Sung S, Al-Karaghouli M, Kalainy S, Cabrera Garcia L, Abraldes JG. (2021). A systematic review on pharmacokinetics, cardiovascular outcomes and safety profiles of statins in cirrhosis. BMC Gastroenterol. (Systematic review of literature suggests that rosuvastatin and pitavastatin pharmacokinetics are unchanged in patients with Child’s Class A cirrhosis as opposed to atorvastatin and pravastatin, although unlike rosuvastatin, simvastatin, atorvastatin and pravastatin have been assessed in clinical trials in cirrhotic patients).
Lu B, Sun L, Seraydarian M, Hoffmann TJ, Medina MW, Risch N, Iribarren C, et al. (2021). Effect of SLCO1B1 T521C on statin-related myotoxicity with use of lovastatin and atorvastatin. Clin Pharmacol Ther. (Among 233 patients with statin associated myopathy and 2342 controls selected from an aging cohort with genetic testing, the allele frequency of c.521T>C in SLCO1B1 [rs4149056] was higher in those with myopathy, C allele frequency being 14-15% of controls compared to 17% of atorvastatin [p=0.4], 19% of lovastatin [p<0.001], and 25% of simvastatin [p<0.001] myopathy cases).
Cai T, Abel L, Langford O, Monaghan G, Aronson JK, Stevens RJ, Lay-Flurrie S, et al. (2021). Associations between statins and adverse events in primary prevention of cardiovascular disease: systematic review with pairwise, network, and dose-response meta-analyses. BMJ. (Systematic review of placebo controlled trials of statins for cardiovascular disease prevention identified 62 publications with 120,456 patients and found an increased risk of muscle symptoms, liver test abnormalities, renal insufficiency and eye conditions for all 7 statins, but not muscle disorders or diabetes; rosuvastatin having relatively high risk for muscle symptoms and renal abnormalities and also was also associated with eye conditions and diabetes while atorvastatin and lovastatin had highest risk for liver abnormalities).
Alanazi NS, Alenazi TS, Alenzi KA. (2021). Hepatotoxicity induced by fluvastatin: a reversible acute cholestatic liver injury. Am J Case Rep. (69 year old man with hyperlipidemia and diabetes was switched from simvastatin [20 mg] to Fluvastatin [40 mg] once daily and developed fatigue, itching, dark urine and jaundice 6-7 weeks later [bilirubin 18.5 mg/dL, ALT 108 U/L, Alk P 1200 U/L, CPK 4200 U/L, INR 1.1], with worsening for a week and then slow resolution after stopping fluvastatin).

## OTHER REFERENCE LINKS

1 Recent References on Fluvastatin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=fluvastatin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Fluvastatin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=fluvastatin)